# Canakinumab

## OVERVIEW

### Introduction

Canakinumab is a monoclonal antibody to interleukin-1 (IL-1) beta which is used in the therapy of juvenile idiopathic arthritis and other autoinflammatory conditions. Canakinumab is a relatively new biologic agent, has had limited clinical use, but has yet to be linked to cases of clinically apparent, acute liver injury.

### Background

Canakinumab (kan” a kin’ ue mab) is a human monoclonal antibody to IL-1 beta. The antibody reactivity is specific for IL-1 beta with no cross reactivity to other members of the IL-1 family or other cytokines. IL-1 is a key proinflammatory cytokine that medicates local and systemic inflammatory reactions and can induce fever, pain sensitization, bone and cartilage destruction and acute phase plasma protein reactions. In several controlled trials and open label studies, canakinumab has been shown to improve symptoms and laboratory abnormalities associated with juvenile idiopathic arthritis (formerly juvenile rheumatoid arthritis or Still disease) and several rare autoinflammatory conditions such as cryopyrin associated periodic syndrome (CAPS), Schnitzler syndrome and familial Mediterranean fever. Canakinumab was approved for use in periodic fever syndromes in the United States in 2009 and indications were later expanded to include juvenile idiopathic arthritis, Familial Mediterranean Fever, hyperimmunoglobulin D syndrome, and tumor necrosis factor receptor associated periodic syndrome (TRAPS). Canakinumab is considered a disease modifying antirheumatic drug (DMARD), and improves signs and symptoms of disease and decreases cartilage and tissue destruction. For juvenile idiopathic arthritis, canakinumab is given by subcutaneous injection every 8 weeks in a dose of 4 mg/kg (for patients weighing >7.5 kg) with a maximum dose of 300 mg. Lower doses are used in cryopyrin associated periodic syndromes. The most frequent side effects are local skin reactions, gastrointestinal upset, diarrhea, vertigo and possibly an increased incidence of bacterial infections. Uncommon but potentially severe adverse events include severe infections, immunosuppression, macrophage activation syndrome and hypersensitivity reactions.

### Hepatotoxicity

In large registration trials, ALT elevations occurred in 1% to 4% of patients taking canakinumab, a rate similar to or minimally above that in placebo recipients. Serum aminotransferase levels are often raised in children with juvenile idiopathic arthritis and adult onset Still disease, and instances of improvement in serum enzyme elevations with initiation of canakinumab therapy have been reported. There have been no published reports of clinically apparent liver injury with jaundice attributed to canakinumab. On the other hand, in large case series and registries, adverse events of hepatobiliary disorders and hepatitis have been reported. Some of these may have been instances of macrophage activation syndrome arising during therapy, a severe complication of inflammatory arthritides that can be accompanied by hepatic injury. Canakinumab has had limited clinical use, but hepatic injury with jaundice due to canakinumab must be rare, if it occurs. In addition, canakinumab has not been linked to cases of reactivation of hepatitis B or exacerbation of chronic hepatitis C which can occur with other cytokines and anticytokines.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Canakinumab is a monoclonal antibody and has minimal hepatic metabolism. The mechanism by which it causes serum enzyme elevations during therapy is unknown, but may be the result of its effects on the immune system or on the IL-1 pathways which are important in inflammation and cell damage.

### Outcome and Management

Agents that block the proinflammatory pathways of IL-1 and IL-6 share similar activity against autoinflammatory diseases and have little evidence for hepatotoxicity. However, there is no reason to suspect that there may be cross sensitivity to hepatic injury between canakinumab and other IL-1 antagonists such as anakinra and rilonacept or other immune modulating biologic agents such as tocilizumab or tumor necrosis factor antagonists.

Drug Class: Antirheumatic Agents

Other Drugs in the Subclass, Interleukin Receptor Antagonists: Anakinra, Rilonacept, Sarilumab, Tocilizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Canakinumab – Ilaris®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Canakinumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Canakinumab | 914613-48-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2020

Abbreviations: IL1, interleukin 1; CAPS, cryopyrin-associated periodic syndrome; DMARD, disease modifying anti-rheumatic drug; TRAPS, tumor necrosis factor receptor associated periodic syndrome.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999 before the availability of canakinumab and the IL-1 blockers).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
Bywaters EG. (1971). Still's disease in the adult. Ann Rheum Dis. (Clinical description of 14 patients with adult onset Still disease seen at a single referral center in the UK over a 25 year period; all woman, ages 17 to 35 years, presenting with urticarial, macular rash, high fevers, fatigue and arthritis, high ESR but no rheumatoid factor, the majority ultimately recovering completely without residual arthritis or problems).
Andrès E, Kurtz JE, Perrin AE, Pflumio F, Ruellan A, Goichot B, Dufour P, et al. (2003). Retrospective monocentric study of 17 patients with adult Still's disease, with special focus on liver abnormalities. Hepatogastroenterology. (Among 17 patients with adult onset Still disease seen at a single French referral center, mean age was 27 years and 76% had "moderate liver dysfunction" with hepatomegaly in 47%, bilirubin 0.6-1.3 mg/dL and ALT 32-252 U/L, all eventually having a "complete recovery").
Efthimiou P, Georgy S. (2006). Pathogenesis and management of adult-onset Still's disease. Semin Arthritis Rheum. (Adult onset Still disease is a rare, systemic inflammatory disorder of unknown cause characterized by fever, distinctive skin rash, arthritis and multiorgan involvement).
Zhu G, Liu G, Liu Y, Xie Q, Shi G. (2009). Liver abnormalities in adult onset Still's disease: a retrospective study of 77 Chinese patients. J Clin Rheumatol. (Retrospective analysis of clinical features of 77 patients with adult onset Still disease presenting at a single referral center in China reported hepatomegaly in 12%, ALT or AST elevations in 62%, values >5 times ULN in 16% [some on therapy], hepatitis with jaundice in 8%; 2 patients developed acute liver failure and one died, the rest recovered without residual injury).
Lachmann HJ, Kone-Paut I, Kuemmerle-Deschner JB, Leslie KS, Hachulla E, Quartier P, Gitton X, et al., Canakinumab in CAPS Study Group. (2009). Use of canakinumab in the cryopyrin-associated periodic syndrome. N Engl J Med. (Among 35 patients with CAPS from 11 centers in 5 countries treated with either canakinumab or placebo in various regimens, 34 of 35 receiving canakinumab had a clinical remission which was maintained in those who continued drug; ALT elevations [>5 times ULN] occurred in 1 treated patient [3%]).
Furst DE. (2010). The risk of infections with biologic therapies for rheumatoid arthritis. Semin Arthritis Rheum. (Review of the excess risk of infections during biologic therapy of rheumatoid arthritis mentions that the rate of infections was 2.1% in anakinra treated patients vs 0.4% in controls; infections were primarily pneumonia and skin infections, none were fatal and few were opportunistic infections).
So A, De Meulemeester M, Pikhlak A, Yücel AE, Richard D, Murphy V, Arulmani U, et al. (2010). Canakinumab for the treatment of acute flares in difficult-to-treat gouty arthritis: Results of a multicenter, phase II, dose-ranging study. Arthritis Rheum. (Among 200 patients with an attack of acute gouty arthritis, ALT elevations occurred in 2 of 143 patients [1.4%] given a single dose of canakinumab, but in 0 of 57 [0%] given a single dose of triamcinolone).
Carroll MB. (2011). The impact of biologic response modifiers on hepatitis B virus infection. Expert Opin Biol Ther. (Review of reactivation of hepatitis B by biologic response modifiers; canakinumab has not been linked to reactivation of HBV, but experience with its use has been limited).
Koné-Paut I, Lachmann HJ, Kuemmerle-Deschner JB, Hachulla E, Leslie KS, Mouy R, Ferreira A, et al., Canakinumab in CAPS Study Group. (2011). Sustained remission of symptoms and improved health-related quality of life in patients with cryopyrin-associated periodic syndrome treated with canakinumab: results of a double-blind placebo-controlled randomized withdrawal study. Arthritis Res Ther. (Further follow up on 31 patients with CAPS treated with canakinumab [Lachmann 2009] focusing upon quality of life; no mention of ALT elevations or hepatotoxicity).
Kuemmerle-Deschner JB, Hachulla E, Cartwright R, Hawkins PN, Tran TA, Bader-Meunier B, Hoyer J, et al. (2011). Two-year results from an open-label, multicentre, phase III study evaluating the safety and efficacy of canakinumab in patients with cryopyrin-associated periodic syndrome across different severity phenotypes. Ann Rheum Dis. (Open label study of canakinumab [every 8 weeks for up to 2 years] in 166 patients with CAPS; predominant adverse effects were infections [66%]; "biochemistry evaluations at the end of the study showed no clinically significant changes from baseline").
Rubbert-Roth A. (2012). Assessing the safety of biologic agents in patients with rheumatoid arthritis. Rheumatology (Oxford). (Overview of safety of biologic agents in rheumatoid arthritis discusses anakinra, but not canakinumab).
(2012). Drugs for rheumatoid arthritis. Treat Guidel Med Lett. (Concise summary on current therapies of rheumatoid arthritis discusses anakinra and tocilizumab, but not canakinumab).
Ruperto N, Brunner HI, Quartier P, Constantin T, Wulffraat N, Horneff G, Brik R, et al. (2012). PRINTO; PRCSG. Two randomized trials of canakinumab in systemic juvenile idiopathic arthritis. N Engl J Med. (Among 177 patents with systemic juvenile arthritis treated with canakinumab [4 mg/kg] every 8 weeks for 12 to 32 weeks, the major adverse effects were infections [55%]; although median values for ALT and AST did not change during therapy, values ranged from 5-82 U/L before therapy and were 7-828 at the end of 29 days and 0-282 U/L at the end of an open label phase [12-32 weeks]).
Sandborg C, Mellins ED. (2012). A new era in the treatment of systemic juvenile idiopathic arthritis. N Engl J Med. (Editorial in response to Ruperto [2012] and De Benedetti [2012] on IL-1 antagonists as therapy of juvenile idiopathic arthritis; "the therapeutic benefits of these biologic agents will need to be weighed against the apparent risks of infection, neutropenia and liver dysfunction").
Dinarello CA, Simon A, van der Meer JW. (2012). Treating inflammation by blocking interleukin-1 in a broad spectrum of diseases. Nat Rev Drug Discov. (Review of the biologic actions of IL-1 and the clinical efficacy and safety of agents that block its activity including anakinra [IL-1Ra], canakinumab [monoclonal antibody to IL-1 beta] and rilonacept [recombinant soluble IL-1 receptor]).
Brizi MG, Galeazzi M, Lucherini OM, Cantarini L, Cimaz R. (2012). Successful treatment of tumor necrosis factor receptor-associated periodic syndrome with canakinumab. Ann Intern Med. (35 year old woman with TRAPS had a beneficial response to course of canakinumab; no mention of hepatotoxicity).
Schlesinger N, Alten RE, Bardin T, Schumacher HR, Bloch M, Gimona A, Krammer G, et al. (2012). Canakinumab for acute gouty arthritis in patients with limited treatment options: results from two randomised, multicentre, active-controlled, double-blind trials and their initial extensions. Ann Rheum Dis. (Controlled trial of single dose of canakinumab in patients with an attack of acute gouty arthritis; ALT elevations [>3 times ULN] occurred in 4 of 225 [2%] treated with canakinumab vs 7 of 229 [3%] given triamcinolone).
Kontzias A, Efthimiou P. (2012). The use of Canakinumab, a novel IL-1β long-acting inhibitor, in refractory adult-onset Still's disease. Semin Arthritis Rheum. (38 year old man and 36 year old woman with adult onset Still disease who were resistant to treatment with prednisone, methotrexate and anakinra had a complete and maintained response to canakinumab; no mention of side effects or ALT levels on treatment).
Miyamae T. (2012). Cryopyrin-associated periodic syndromes: diagnosis and management. Paediatr Drugs. (Review of the clinical features, pathogenesis and therapy of CAPS with specific discussion of anakinra, rilonacept and canakinumab; no mention of hepatotoxicity).
Ruperto N, Quartier P, Wulffraat N, Woo P, Ravelli A, Mouy R, Bader-Meunier B, et al., Paediatric Rheumatology International Clinical Trials Organisation. (2012). A phase II, multicenter, open-label study evaluating dosing and preliminary safety and efficacy of canakinumab in systemic juvenile idiopathic arthritis with active systemic features. Arthritis Rheum. (Open label, dose escalation study of canakinumab in 23 children with juvenile idiopathic arthritis treated for up to 6 months; "There were no clinically relevant changes in the laboratory findings").
Vanderschueren S, Knockaert D. (2013). Canakinumab in Schnitzler syndrome. Semin Arthritis Rheum. (37 year old man with Schnitzler syndrome resistant to other therapies [including anakinra] had an immediate and sustained response to canakinumab; "chemistry laboratory values were monitored and no abnormalities were observed").
Moran A, Bundy B, Becker DJ, DiMeglio LA, Gitelman SE, Goland R, Greenbaum CJ, et al. (2013). Type 1 Diabetes TrialNet Canakinumab Study Group; AIDA Study Group. Interleukin-1 antagonism in type 1 diabetes of recent onset: two multicentre, randomised, double-blind, placebo-controlled trials. Lancet. (Two parallel trials comparing anakinra or canakinumab to placebo is 69 patients with recent onset of type 1 diabetes found no evidence of benefit and similar side effects of both drugs; no mention of ALT elevations or hepatotoxicity).
Akgul O, Kilic E, Kilic G, Ozgocmen S. (2013). Efficacy and safety of biologic treatments in familial Mediterranean fever. Am J Med Sci. (Systematic review of reports on biologic response modifiers in familial Mediterranean fever identified no controlled trials, but 24 single reports and 7 case series describing 59 patients, 35 on anti-TNF agents, 29 anakinra, 4 canakinumab; 2 had adverse events that required stopping, but the rest seemed to have a beneficial effect; no discussion of hepatotoxicity).
(2013). Canakinumab (Ilaris) for systemic juvenile idiopathic arthritis. Med Lett Drugs Ther. (Concise review of the pharmacology, mechanism of action, efficacy and safety of canakinumab shortly after its approval for juvenile idiopathic arthritis in the US; mentions that neutropenia, thrombocytopenia and elevated aminotransferases have been reported with its use).
Banse C, Vittecoq O, Benhamou Y, Gauthier-Prieur M, Lequerré T, Lévesque H. (2013). Reactive macrophage activation syndrome possibly triggered by canakinumab in a patient with adult-onset Still's disease. Joint Bone Spine. (49 year old woman with Still disease developed suspected macrophage activation syndrome after a second infusion of canakinumab with high fever, abdominal pain and hepatomegaly [bilirubin not given, ALT 20 times ULN], resolving with high dose glucocorticoid therapy).
Wulffraat NM. (2015). A safety evaluation of canakinumab for the treatment of systemic onset juvenile idiopathic arthritis. Expert Opin Drug Saf. (Systematic review of the adverse events associated with canakinumab therapy focuses on common events such as abdominal pain, injection site reactions and infections and the more serious events such as septicemia and macrophage activation syndrome; no mention of ALT elevations or hepatotoxicity).
Krause K, Tsianakas A, Wagner N, Fischer J, Weller K, Metz M, Church MK, et al. (2017). Efficacy and safety of canakinumab in Schnitzler syndrome: A multicenter randomized placebo-controlled study. J Allergy Clin Immunol. (Among 20 patients with Schnitzler syndrome treated with canakinumab or placebo for 7 days followed by open label therapy, canakinumab was associated with marked clinical improvements in most patients and "no significant changes in safety laboratory parameters were observed").
Tarp S, Amarilyo G, Foeldvari I, Christensen R, Woo JM, Cohen N, Pope TD, et al. (2016). Efficacy and safety of biological agents for systemic juvenile idiopathic arthritis: a systematic review and meta-analysis of randomized trials. Rheumatology (Oxford). (Systematic review of the literature of the safety of biologic agents for juvenile idiopathic arthritis mentions that serious adverse events including infections were no more frequent with canakinumab than placebo therapy; no mention of ALT elevations or hepatotoxicity).
Lenert A, Yao Q. (2016). Macrophage activation syndrome complicating adult onset Still's disease: A single center case series and comparison with literature. Semin Arthritis Rheum. (Description of 7 patients with adult onset Still’s disease who developed macrophage activation syndrome soon after initial presentation manifested by fever, rash, arthralgias, lymphopenia, leukocytosis and liver test abnormalities [mean bilirubin 4.2 mg/dL, ALT 290 U/L, LDH 2167 U/L, INR 1.58] and variable degrees of renal and pulmonary failure and hemophagocytosis present in 3 of 7 bone marrow biopsies, with excellent response to anakinra).
Colafrancesco S, Priori R, Valesini G, Argolini L, Baldissera E, Bartoloni E, Cammelli D, et al. (2017). Response to interleukin-1 inhibitors in 140 Italian patients with adult-onset Still's disease: a multicentre retrospective observational study. Front Pharmacol. (Among 140 patients with adult onset Still’s disease followed at 18 Italian referral centers treated with anakinra, clinical responses were common and the most frequent adverse events were local injection reactions, rash and infections [15%] while hepatomegaly and liver test abnormalities decreased on treatment (from 47% to 5%]; therapy was switched to canakinumab in 4 patients with an unsatisfactory response to anakinra and 3 responded and “no adverse events were registered”).
Arostegui JI, Anton J, Calvo I, Robles A, Iglesias E, López-Montesinos B, Banchereau R, et al. (2017). Open-label, phase II study to assess the efficacy and safety of canakinumab treatment in active hyperimmunoglobulinemia D with periodic fever syndrome. Arthritis Rheumatol. (Among 9 patients with hyperimmunoglobulin D syndrome with periodic fever treated with canakinumab for 6 months, all achieved a complete clinical response, and 7 of the 9 relapsed on withdrawal; adverse events included infections and transient ALT elevations in two patients).
Ruperto N, Brunner HI, Quartier P, Constantin T, Wulffraat NM, Horneff G, Kasapcopur O, et al., Paediatric Rheumatology International Trials Organisation (PRINTO) and the Pediatric Rheumatology Collaborative Study Group (PRCSG). (2018). Canakinumab in patients with systemic juvenile idiopathic arthritis and active systemic features: results from the 5-year long-term extension of the phase III pivotal trials. Ann Rheum Dis. (Among 144 children with juvenile idiopathic arthritis enrolled in controlled trials [Ruperto 2012] who were continued on therapy in extension studies, 102 discontinued treatment because of lack of efficacy while clinical efficacy was maintained in the rest, adverse events included macrophage activation syndrome [6%], hepatitis [1%] and hepatic enzyme elevations [2%]).
Feist E, Quartier P, Fautrel B, Schneider R, Sfriso P, Efthimiou P, Cantarini L, et al. (2018). Efficacy and safety of canakinumab in patients with Still's disease: exposure-response analysis of pooled systemic juvenile idiopathic arthritis data by age groups. Clin Exp Rheumatol. (Pooled analysis of results of canakinumab therapy in 4 clinical trials including 301 patients with juvenile idiopathic arthritis found similar rates of efficacy and adverse events among age groups [0-11 vs 12-15 vs 16-20], macrophage activation syndrome occurring in 22 [7.3%], hepatitis in 4 [1.3%] and liver enzyme elevations in 5 [1.7%]).
Sota J, Vitale A, Insalaco A, Sfriso P, Lopalco G, Emmi G, Cattalini M, et al. (2018). “Working Group” of Systemic Autoinflammatory Diseases of SIR (Italian Society of Rheumatology). Safety profile of the interleukin-1 inhibitors anakinra and canakinumab in real-life clinical practice: a nationwide multicenter retrospective observational study. Clin Rheumatol. (Among 475 patients treated with anakinra or canakinumab for various inflammatory conditions for an average of 24 months, the most frequently reported adverse events were rash, injection site reactions, infections, cytopenias, and anaphylaxis; one patient developed serum enzyme elevations and one macrophage activation syndrome).
Giacomelli R, Ruscitti P, Shoenfeld Y. (2018). A comprehensive review on adult onset Still's disease. J Autoimmun. (Review of the pathogenesis, clinical features, complications and therapy of adult onset Still’s disease mentions that liver test abnormalities have been reported in 37-74% of subjects and that anakinra has been studied in at least 13 small open label trials with response rates of 46-100% and both canakinumab or rilonacept have been found to be helpful in cases with intolerance or an inadequate response to anakinra).
Crayne CB, Albeituni S, Nichols KE, Cron RQ. (2019). The Immunology of macrophage activation syndrome. Front Immunol. (Review of the immunopathogenesis of the macrophage activation syndrome, a complication of several systemic inflammatory disorders including juvenile idiopathic arthritis, systemic lupus erythematosus and adult onset Still’s disease, characterized by high circulating levels of proinflammatory cytokines which has led to the experimental use of cytokine inhibitors such as anakinra or canakinumab).
Brogan PA, Hofer M, Kuemmerle-Deschner JB, Koné-Paut I, Roesler J, Kallinich T, Horneff G, et al. (2019). Rapid and sustained long-term efficacy and safety of canakinumab in patients With cryopyrin-associated periodic syndrome ages five years and younger. Arthritis Rheumatol. (Among 17 children less than 5 years of age with a cryopyrin-associated periodic syndrome treated with canakinumab, all had a complete clinical response and adverse events included diarrhea, pneumonia, rhinitis, fever and cough but none led to discontinuation; no mention of ALT elevations or hepatotoxicity).
Sfriso P, Bindoli S, Doria A, Feist E, Galozzi P. (2020). Canakinumab for the treatment of adult-onset Still's disease. Expert Rev Clin Immunol. (Review of the clinical efficacy and safety of canakinumab for adult-onset Still’s disease for which it is not approved in the US, despite evidence for its efficacy in small case series and clinical trials; the most concerning adverse events reported with canakinumab were diarrhea and macrophage activation syndrome; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Canakinumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Canakinumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Canakinumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Canakinumab)